# Revumenib

## OVERVIEW

### Introduction

Revumenib is a small molecule inhibitor of menin and is used to treat children and adults with relapsed or refractory acute leukemia with a lysine methyltransferase 2A gene translocation. Revumenib is associated with mild-to-moderate elevations in serum aminotransferase levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Revumenib (reh voo meh’ nib) is a small molecule inhibitor of menin and is used to treat children (above the age of 1) and adults with refractory or relapsed acute leukemia with a lysine methyltransferase 2A gene (KMT2A) translocation. Menin is a chromatin adapter protein that is critical for the formation and stability of multiprotein complexes on chromatin including complexes with mutated proteins associated with leukemia, such as KMT2A and NPM1 (nucleophosmin 1). Inhibition of menin by revumenib was found to yield objective response rates in patients with various forms of relapsed or refractory acute leukemia harboring KMT2A rearrangements. In an open label, multi-cohort, multicenter study of revumenib monotherapy, a phase 1 component led to the choice of dose and enrollment criteria for a phase 2 extended treatment study, which yielded a complete response rate of 23% and an overall response rate of 63% for the 57 patients in the pivotal cohort. Based upon these results, revumenib was approved in the United States in 2024 as therapy for adults and children with relapsed or refractory acute leukemia who harbor a genetic variant such as KMT2A translocations. Revumenib is available in tablets of 25, 110 and 160 mg under the brand name Revuforj. The recommended dose regimen is based upon body weight and whether there is concomitant use of strong CYP 3A4 inhibitors; the typical dose in adults not on a CYP inhibitor is 270 mg taken orally twice daily. Therapy should be continued until unacceptable tolerance or disease progression, and optimally for at least six months. Side effects are common and can be severe. Common adverse events include hemorrhage, nausea, vomiting, musculoskeletal pain, infection, diarrhea, constipation, anorexia, edema, and fatigue. Laboratory abnormalities can include increases in serum phosphate, aminotransferases, alkaline phosphatase, and triglycerides, and decreases in neutrophils, phosphate, and potassium. Less frequent but potentially severe adverse events include differentiation syndrome, febrile neutropenia, bacterial infections, prolongation of the QTc interval, and embryo-fetal toxicity. Revumenib has a boxed warning about differentiation syndrome which can be fatal. It also has a warning against concomitant use of agents that prolong the QTc interval and recommends monitoring with EKGs before, weekly for 4 weeks, and monthly thereafter.

### Hepatotoxicity

In the prelicensure trials of revumenib, a safety cohort of 94 participants who received the recommended dose was used to evaluate rates of adverse events. Fatal adverse events arose in 4 patients, 2 from differentiation syndrome, 1 from hemorrhage, and 1 from sudden death. Liver test abnormalities were frequent but usually mild-to-moderate in severity and self-limited in duration. ALT elevations arose in 37%, AST in 40%, alkaline phosphatase in 26%, and bilirubin in 11%, and ALT values were above 5 times the ULN in 4% and AST in 2%. The median time to onset of aminotransferase elevations was 21 days (range 1 to 185 days). However, there were no instances of enzyme elevations with jaundice or symptoms that were attributed to drug therapy. Since approval and clinically availability of revumenib, there have been no published case reports of clinically apparent liver injury, but clinical experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury during revumenib therapy are possibly due to direct toxicity of inhibition of menin facilitated pathways. Revumenib is metabolized in the liver largely via CYP 3A4 and is susceptible to drug-drug interactions with moderate or strong inducers and inhibitors of CYP 3A4. Revumenib is also a CYP 3A inducer that can alter the metabolism of concomitant agents that are CYP 3A substrates.

### Outcome and Management

The product label for revumenib recommends monitoring of liver tests before and monthly during therapy. Serum aminotransferase elevations above 5 times the upper limit of normal or any elevations accompanied by jaundice or symptoms should lead to discontinuation until levels fall to less than twice ULN or an unrelated cause is found. There is little information on cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between revumenib and other kinase inhibitors used in the therapy of acute leukemia, such as ponatinib, enasidenib, and ivosidenib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Revumenib – Revuforj®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Revumenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Revumenib | 2169919-21-3 | C32-H47-FN6-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 7 April 2025

Abbreviations: KMT2A, lysine methyltransferase 2A; NPM1 Nucleophosmin 1; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as revumenib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not revumenib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/218944Orig1s000TOC.cfm (FDA review of the data on efficacy and safety of revumenib submitted by the sponsor in support of its approval for therapy of refractory or relapsed acute leukemia with KMT2A rearrangements, mentions that the safety population included 135 patients with a median treatment duration of only 2.3 months, among whom there were 4 deaths, none from liver disease, and that liver test abnormalities were frequent but usually transient and mild-to-moderate in course, with ALT elevations in 37% and AST in 40%, only 2% and 4% being above 5 times ULN, and there were no cases of drug induced liver injury or concurrent rises in ALT levels and bilirubin that were attributed to drug therapy).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; revumenib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of revumenib which is not discussed). 23620168
Issa GC, Aldoss I, DiPersio J, Cuglievan B, Stone R, Arellano M, Thirman MJ, et al. The menin inhibitor revumenib in KMT2A-rearranged or NPM1-mutant leukaemia. Nature. 2023; 615(7954):920-924. (Description of the mechanism of action of revumenib and role of menin in modulating cell growth proliferation and differentiation with data on a phase 1 trial in 56 patients with relapsed or refractory acute leukemia and either KMT2A or NPPM1 alterations that defined the dose-limiting toxicity [QTc prolongation] and achieved an overall response rate of 53% with adverse events including differentiation syndrome in 16% and ALT elevations in 25%, all of which resolved with discontinuation). 36922593
Issa GC, Aldoss I, Thirman MJ, DiPersio J, Arellano M, Blachly JS, Mannis GN, et al. Menin inhibition with revumenib for KMT2A-rearranged relapsed or refractory acute leukemia (AUGMENT-101). J Clin Oncol. 2025;43:75-84. (In an open label, multicenter trial of dose-escalation followed by an expansion study using the optimal dose of revumenib in heavily pretreated patients with KMT2A rearranged acute leukemia, the modified complete response rate was 23% and overall response rate 63%, while adverse events arose in 99% of patients, led to dose reductions in 10%, discontinuations in 13%, and fatalities in 15%; and included differentiation syndrome in 18%, QTc prolongation in 26%, and aminotransferase elevations in 29%). 39121437
Revumenib (Revuforj) for acute leukemia. Med Lett Drugs Ther. 2025;67: e8-e9. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of revumenib shortly after its approval in the US as therapy of patients with relapsed or refractory acute leukemia with KMT2A, mentions the major adverse events including prolongation of the QTc interval and differentiation syndrome, but does not mention ALT elevations or hepatotoxicity). 39787579
Syed YY. Revumenib: first approval. Drugs. 2025;85:577-583. (Review of the mechanism of action, clinical efficacy, safety, and cost of revumenib as therapy for relapsed or refractory KMT2Ar acute leukemia, mentions that revumenib monotherapy “showed an acceptable safety and tolerable profile”). 40072775

## OTHER REFERENCE LINKS

1. Recent References on Revumenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Revumenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Revumenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Revumenib)